# Immunological Features

Drug induced liver injury is often accompanied by immunological features indicating either hypersensitivity or an autoimmune reaction or both. These features range in severity and prominence; they are usually transient and mild, but can be severe and dominant in the clinical picture. Immunological features, of course, point to an immune causality for the liver injury, but in some situations the immunological features may be the result rather than the cause of the liver injury. Two major forms of immune features occur in drug induced liver injury: immunoallergic and autoimmune features. These patterns are usually, but not invariably distinct. The presence of immunological features is often helpful in the diagnosis of drug induced liver injury and sometimes helps to identify the causative agent.

Immunoallergic hepatitis is accompanied by variable combinations of skin rash, fever, lymphadenopathy, facial edema, myaglias, arthraglia, eosinophilia and atypical lymphocytosis. Immunoallergic hepatitis is most frequent with cholestatic or mixed forms of acute hepatitis due to medications, but also occurs with purely hepatocellular injury, as well as with enzyme elevations without jaundice and some instances of chronic hepatitis due to medications. Immunoallergic hepatitis usually has a short latency and abrupt onset and is most typical of the aromatic anticonvulsants, allopurinol, sulfonamides and fluoroquinolones. The most dramatic forms of immunoallergic hepatitis are often referred to as DRESS syndrome (drug reaction with eosinophilia and systemic symptoms) and may include Stevens Johnson syndrome or toxic epidermal necrosis.

Autoimmune hepatitis is marked by the presence of autoantibodies (most typically antinuclear antibody) and hyperglobulinemia accompanying the liver injury. Autoimmune hepatitis induced by medications usually has a long latency (sometimes years), insidious onset and a hepatocellular pattern of serum enzyme elevations. Liver histology in autoimmune forms of drug induced liver injury resembles the pattern seen in spontaneous or idiopathic autoimmune hepatitis. The medications most frequently linked to drug induced autoimmune hepatitis include nitrofurantoin, minocycline, hydralazine and methyldopa.

Immunoallergic Hepatitis

Autoimmune Hepatitis